# Ofatumumab

## OVERVIEW

### Introduction

Ofatumumab is a recombinant human monoclonal antibody to CD20 a cell surface antigen found on pre-B and mature B lymphocytes and which is approved for use in resistant chronic lymphocytic leukemia. Ofatumumab therapy has not been associated with serum enzyme elevations during therapy or to cases of idiosyncratic, clinically apparent liver injury. However, ofatumumab has potent immunosuppressive activity and its use has been reported to be associated with cases of reactivation of inactive hepatitis B which can be severe and can result in fatality.

### Background

Ofatumumab (oh” fa toom’ ue mab) is a human monoclonal IgG1 antibody to the cell surface antigen CD20 (also known as human B lymphocyte restricted differentiation antigen: Bp35), which is found on mature B cells as well as 90% of neoplastic B cell such as occur in chronic lymphocytic leukemia (CLL). CD20 is not present on pro-B cells, hematopoietic stem cells, normal plasma cells or other normal lymphocytes, circulating cells or tissues. Engagement of ofatumumab with CD20 leads to B cell lysis and depletion of circulating and tissue B cells for an extended period, up to 6 to 8 months. There is an accompanying mild decrease in IgM, but no change in IgG or IgA levels. Ofatumumab was approved for use in previously treated, resistant chronic lymphocyte leukemia in the United States in 2009. Ofatumumab is available in liquid solution in single use vials of 100 and 1000 mg (20 mg/mL) under the brand name Arzerra. The dose and regimen varies by indication, but it is usually given intravenously in 300 to 2000 mg amounts in 28 day cycles. Common side effects include infusion reactions, chills, fever, nausea, diarrhea, fatigue, dyspnea, cough, bronchitis, pneumonia, skin rash, neutropenia and infections. Less common, but potentially severe side effects include cutaneous reactions (Stevens Johnson syndrome), tumor lysis syndrome, prolonged neutropenia, thrombocytopenia and anemia. Because of the potential severity of infusion reactions, premedication with antihistamines, acetaminophen and corticosteroids is recommended, and ofatumumab should be administered under close medical observation.

### Hepatotoxicity

Serum aminotransferase elevations are uncommon during ofatumumab therapy and rarely mentioned in large clinical trials of its use in CLL and autoimmune diseases. Clinically apparent liver injury has not been reported with ofatumumab therapy either in prelicensure clinical trials or subsequent to its more widescale clinical use.

On the other hand, ofatumumab is a potent immunosuppressive agent and has been reported to cause reactivation of hepatitis B by the FDA. However, there have been no examples of reactivation published in the medical literature and specific features of the reactivation caused by ofatumumab have not been described. Typically, HBV reactivation is associated with acute hepatocellular injury similar to acute viral hepatitis that can be severe and lead to acute liver failure and death or need for emergency liver transplantation. If detected early, however, therapy with antiviral agents can blunt the severity of injury. In contrast, rituximab, another monoclonal antibody to CD20 that has been extensively used for several decades, is perhaps the best and mostly commonly described cause of HBV reactivation. Because ofatumumab, like rituximab, is a monoclonal antibody to CD20, it should have a similar effect on inactive or latent hepatitis B.

Reactivation typically occurs in patients who are HBsAg carriers with inactive hepatitis B who undergo chemotherapy for cancer. Reactivation can also occur in persons who have recovered from hepatitis B, who have no detectable HBsAg but have antibody to hepatitis B core antigen (anti-HBc), with or without antibody to HBsAg (anti-HBs) in serum. The onset of liver injury is delayed and may occur after 3 to 6 monthly courses of immunosuppressive therapy. The usual sequence of events is appearance of rising levels of HBV DNA in serum shortly after chemotherapy is started, followed by a rise in levels of HBsAg and HBeAg. When therapy is stopped and immune reconstitution has begun, serum ALT and AST levels start to rise followed by symptoms and jaundice. Reactivation of hepatitis B tends to be severe and the mortality rate in jaundiced cases exceeds 10%. Liver histology demonstrates an acute hepatitis-like pattern with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, which is compatible with an immune mediated hepatic injury. Restarting chemotherapy can result in recurrence of injury, although concurrent antiviral treatment may block recurrence.

Reactivation of HBV in persons who have resolved hepatitis B (anti-HBc without HBsAg in serum) is usually referred to as “reverse seroconversion”, and reactivation in persons with preexisting HBsAg in serum as “typical” or classical HBV reactivation. The two forms of reactivation have somewhat different clinical, biochemical and virology courses. In general, patients with reverse seroconversion have received more rigorous immunosuppression, the latency until onset is longer, peak levels of HBV DNA are lower, and the disease course is more severe than in patients with typical reactivation. The time to appearance of clinically apparent reactivation tends to be 3 to 6 months in patients with typical reactivation, but 12 to 36 months in those with reverse seroconversion. Outcomes may also be different, reverse seroconversion tending to be more severe and more likely to resolve with disappearance of HBsAg than typical reactivation. Exceptions occur in both situations; however, some patients with reverse seroconversion do not revert back to being HBsAg negative, particularly those who have had hematopoietic cell transplantation (HCT). In addition, some patients with classic reactivation of hepatitis B ultimately clear HBsAg as a result of the acute liver injury. Both forms of reactivation appear to be ameliorated by early intervention with oral antiviral therapy, but institution of therapy after appearance of clinical disease and jaundice may not be effective and many instances of fatal reactivation have occurred despite treatment with oral antiviral agents. Many cases of reverse seroconversion have been reported with rituximab therapy; the occurrence with ofatumumab has been implied, but specific cases have not been published.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury in reactivation of hepatitis B appears to be a brisk immunological response to viral antigens. Injury generally arises after immunosuppressive or cancer chemotherapy has stopped or between courses of treatment. Rituximab is also known to cause an acute autoimmune-like hepatitis, unrelated to reactivation. Ofatumumab has not been shown to cause this type of drug-induced liver injury.

### Outcome and Management

Guidelines for management of patients who are to receive ofatumumab recommend routine screening for hepatitis B before starting treatment. Screening should include tests for HBsAg and anti-HBc (and perhaps also anti-HBs as this may help in management). Prophylaxis with a potent oral, antiviral agent effective against hepatitis B is recommended for all persons who have HBsAg in serum and is suggested for those with anti-HBc without HBsAg. An alternative approach is careful monitoring for HBV DNA during therapy and early institution of antiviral therapy if levels rise. This approach, however, is problematic in that reactivation may occur late during chemotherapy or even after it is completed. The choice of antiviral agents includes lamivudine, telbivudine, adefovir, tenofovir or entecavir. All are given once a day and are extremely well tolerated. Lamivudine is less expensive than the other agents, but is associated with a high rate of antiviral resistance, particularly if given for more than 6 months. Tenofovir and entecavir are the most potent and have high barriers to antiviral resistance, which is important if long term therapy is planned. However, there are no prospectively acquired controlled studies to support use of one of these agents over another. Finally, the appropriate duration of treatment is unclear. The typical recommendation is to continue antivirals for at least 6 months after stopping cancer chemotherapy, but cases of reactivation following withdrawal of antiviral therapy (including fatal instances) have been described and some degree of monitoring during withdrawal of antiviral therapy is appropriate with early re-intervention of HBV DNA levels rise. In patients with anti-HBc without HBsAg, boosting titers of anti-HBs before or in-between treatment courses may be helpful in preventing reactivation. However, patients with lymphoma or autoimmune conditions and those who are receiving ofatumumab generally have poor responses to vaccination and this approach has not been critically evaluated in prospective controlled studies.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ofatumumab – Arzerra®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Ofatumumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ofatumumab | 679818-59-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2020

Abbreviations: CLL, chronic lymphocytic leukemia; HCT, hematopoietic cell transplantation; TNF, tumor necrosis factor; PML, progressive multifocal leukoencephalopathy.
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the tumor necrosis factor [TNF] alpha antagonists"; no specific discussion of ofatumumab).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2009/125326s000_MedR.pdf (pages 102-181). (FDA website with medical review that formed the basis of the initial approval of ofatumumab as therapy for CLL mentions that there were no hepatic deaths and few liver related serious adverse events but recommended product label warning about reactivation of HBV because of the experience with rituximab).
Yeo W, Chan PK, Zhong S, Ho WM, Steinberg JL, Tam JS, Hui P, et al. (2000). Frequency of hepatitis B virus reactivation in cancer patients undergoing cytotoxic chemotherapy: a prospective study of 626 patients with identification of risk factors. J Med Virol. (Among 71 Chinese patients with HBsAg who underwent cancer chemotherapy [not with rituximab] for various malignancies, 15 developed reactivation of HBV, including 6 with jaundice and 3 with acute liver failure, but none died).
Hagenbeek A, Gadeberg O, Johnson P, Pedersen LM, Walewski J, Hellmann A, Link BK, et al. (2008). First clinical use of ofatumumab, a novel fully human anti-CD20 monoclonal antibody in relapsed or refractory follicular lymphoma: results of a phase 1/2 trial. Blood. (In a pilot study of ofatumumab in 40 patients with refractory lymphoma, "no significant changes in serum chemistry were observed").
Coiffier B, Lepretre S, Pedersen LM, Gadeberg O, Fredriksen H, van Oers MH, Wooldridge J, et al. (2008). Safety and efficacy of ofatumumab, a fully human monoclonal anti-CD20 antibody, in patients with relapsed or refractory B-cell chronic lymphocytic leukemia: a phase 1-2 study. Blood. (Pilot study of ofatumumab in escalating doses once weekly for 4 weeks in 33 patients with refractory CLL, the maximum tolerated dose was not reached, one patient developed "cytolytic hepatitis"; a 74 year old man who had elevated tests the day of the first infusion, but also had abnormal values before therapy).
Østergaard M, Baslund B, Rigby W, Rojkovich B, Jorgensen C, Dawes PT, Wiell C, et al. (2010). Ofatumumab, a human anti-CD20 monoclonal antibody, for treatment of rheumatoid arthritis with an inadequate response to one or more disease-modifying antirheumatic drugs: results of a randomized, double-blind, placebo-controlled, phase I/II study. Arthritis Rheum. (Two studies of ofatumumab in patients with resistant rheumatoid arthritis given two infusions of ofatumumab [at 3 different doses] or placebo 2 weeks apart in 264 patients; B cell depletion occurred in all doses and response rates ranged from 40-49% [vs 11% in controls]; side effects were common, but usually mild to moderate in severity and no significant changes were found in routine laboratory results).
Ofatumumab (Arzerra) for CLL. (2010). Med Lett Drugs Ther. (Concise review of efficacy, safety and cost of ofatumumab in CLL shortly after its approval in the US; mentions that severe side effects include infusion reactions, cytopenias, opportunistic infections and progressive multifocal leukoencephalopathy [PMLE]; no mention of hepatotoxicity or ALT elevations).
Taylor PC, Quattrocchi E, Mallett S, Kurrasch R, Petersen J, Chang DJ. (2011). Ofatumumab, a fully human anti-CD20 monoclonal antibody, in biological-naive, rheumatoid arthritis patients with an inadequate response to methotrexate: a randomised, double-blind, placebo-controlled clinical trial. Ann Rheum Dis. (Among 260 patients with rheumatoid arthritis treated with ofatumumab or placebo [two infusions 2 weeks apart], clinical responses at week 24 were more frequent with ofatumumab [50%] than placebo [27%], and common side effects were rash [21%] and urticaria [12%], but there were no liver related serious adverse events and ALT elevations were not reported).
Nightingale G. (2011). Ofatumumab: a novel anti-CD20 monoclonal antibody for treatment of refractory chronic lymphocytic leukemia. Ann Pharmacother. (Review of the mechanism of action, pharmacology, efficacy and safety of ofatumumab; no mention of hepatotoxicity or ALT elevations).
Schmedt N, Andersohn F, Garbe E. (2012). Signals of progressive multifocal leukoencephalopathy for immunosuppressants: a disproportionality analysis of spontaneous reports within the US Adverse Event Reporting System (AERS). Pharmacoepidemiol Drug Saf. (Analysis of spontaneous adverse event reporting of PML in the US between 2004-2010 identified 635 cases with higher than expected number of cases from several immunosuppressive monoclonal antibodies, including rituximab [n=124], natalizumab [123] and efalizumab [12], but not ofatumumab).
Hwang JP, Vierling JM, Zelenetz AD, Lackey SC, Loomba R. (2012). Hepatitis B virus management to prevent reactivation after chemotherapy: a review. Support Care Cancer. (Review of reactivation of HBV from chemotherapy stresses need for routine screening for HBV markers, particularly for patients who are to receive rituximab).
Mitka M. (2013). FDA: Increased HBV reactivation risk with ofatumumab or rituximab. JAMA. (News report of the FDA alert to physicians of the high risk of HBV reactivation in patients receiving ofatumumab or rituximab).
Hsu C, Tsou HH, Lin SJ, Wang MC, Yao M, Hwang WL, Kao WY, et al., Taiwan Cooperative Oncology Group. (2014). Chemotherapy-induced hepatitis B reactivation in lymphoma patients with resolved HBV infection: A prospective study. Hepatology. (Among 150 patients with non-Hodgkin lymphoma who had anti-HBc without HBsAg in serum and were treated with rituximab containing regimens without prophylaxis and followed with monthly testing for HBV DNA, 27 [18%] developed HBV reactivation 3-57 weeks after starting chemotherapy [6 after stopping], 12 developed HBsAg, 7 HBeAg and 10 ALT elevations despite prompt therapy with entecavir, but none had acute liver failure or died).
Kim SJ, Hsu C, Song YQ, Tay K, Hong XN, Cao J, Kim JS, et al. (2013). Hepatitis B virus reactivation in B-cell lymphoma patients treated with rituximab: analysis from the Asia Lymphoma Study Group. Eur J Cancer. (Retrospective analysis of rates of HBV reaction in 340 patients with lymphoma receiving rituximab based chemotherapy identified HBV reactivation in 45 of 162 [28%] of HBsAg positive and 10% of HBsAg negative but anti-HBc positive patients, risk factors being lack of antiviral prophylaxis and absence of anti-HBs and failures of prophylaxis being mostly due to lamivudine rather than entecavir).
Huang YH, Hsiao LT, Hong YC, Chiou TJ, Yu YB, Gau JP, Liu CY, et al. (2013). Randomized controlled trial of entecavir prophylaxis for rituximab-associated hepatitis B virus reactivation in patients with lymphoma and resolved hepatitis B. J Clin Oncol. (Among 80 Chinese patients with lymphoma and anti-HBc without HBsAg in serum, 41 received entecavir and 39 were monitored during rituximab based chemotherapy; reactivation of HBV occurred in 2% on entecavir [1 patient after stopping prophylaxis] versus 18% of controls; while HBsAg reverse seroconversion occurred in 0% on entecavir and 10% of controls; only 1 patient developed hepatitis and none had acute liver failure).
Martin ST, Cardwell SM, Nailor MD, Gabardi S. (2014). Hepatitis B reactivation and rituximab: a new boxed warning and considerations for solid organ transplantation. Am J Transplant. (Commentary on the boxed warning for rituximab and ofatumumab published by the FDA in September 2013, questioning the need for prophylaxis in patients undergoing solid organ transplant who typically receive a single dose of rituximab and in whom there have been few reports of reactivation).
Sorensen PS, Lisby S, Grove R, Derosier F, Shackelford S, Havrdova E, Drulovic J, et al. (2014). Safety and efficacy of ofatumumab in relapsing-remitting multiple sclerosis: a phase 2 study. Neurology. (Among 38 patients with relapsing multiple sclerosis treated with two infusions of 3 doses of ofatumumab or placebo 2 weeks apart and followed for 24 weeks, new brain lesions were less on magnetic resonance imaging after ofatumumab therapy and "results of clinical laboratory tests... were unremarkable").
Mikulska M, Nicolini L, Signori A, Rivoli G, Del Bono V, Raiola AM, Di Grazia C, et al. (2014). Hepatitis B reactivation in HBsAg-negative/HBcAb-positive allogeneic haematopoietic stem cell transplant recipients: risk factors and outcome. Clin Microbiol Infect. (Among 754 patients undergoing hematopoietic cell transplantation, 14 patients developed HBV reactivation, occurring among the 137 who had anti-HBc without HBsAg before transplant at a rate of 2% at one year rising to 26% at 7 years; risk factors included lack of HBV immunity in the donor and length of therapy with cyclosporine).
Yazici O, Sendur MA, Aksoy S. (2014). Hepatitis C virus reactivation in cancer patients in the era of targeted therapies. World J Gastroenterol. (Systematic review of studies of HCV reactivation in patients receiving monoclonal antibody and immunomodulatory therapies for cancer found little evidence that hepatitis C is worsened, but advised caution regardless).
Byrd JC, Brown JR, O'Brien S, Barrientos JC, Kay NE, Reddy NM, Coutre S, et al. (2014). RESONATE Investigators. Ibrutinib versus ofatumumab in previously treated chronic lymphoid leukemia. N Engl J Med. (Among 391 patients with relapsed or refractory CLL treated with daily ibrutinib or monthly infusions of ofatumumab overall survival was better with ibrutinib as were serious adverse events [57% vs 47%], but there were no liver related serious adverse events and no mention of elevations in ALT levels).
Di Bisceglie AM, Lok AS, Martin P, Terrault N, Perrillo RP, Hoofnagle JH. (2015). Recent US Food and Drug Administration warnings on hepatitis B reactivation with immune-suppressing and anticancer drugs: just the tip of the iceberg?. Hepatology. (Review of the pathogenesis, clinical course, treatment and prevention of HBV reactivation in patients receiving immunosuppressive or anticancer therapies, with particular focus on rituximab and ofatumumab).
Korycka-Wołowiec A, Wołowiec D, Robak T. (2015). Ofatumumab for treating chronic lymphocytic leukemia: a safety profile. Expert Opin Drug Saf. (Review of the efficacy and safety of ofatumumab in CLL mentions that the major non-hematologic toxicity is infections [20%] which can be severe, but that hepatic toxicity is uncommon).
van Oers MH, Kuliczkowski K, Smolej L, Petrini M, Offner F, Grosicki S, Levin MD, et al., PROLONG study investigators. (2015). Ofatumumab maintenance versus observation in relapsed chronic lymphocytic leukaemia (PROLONG): an open-label, multicentre, randomised phase 3 study. Lancet Oncol. (Among 474 patients with CLL treated with ofatumumab or no therapy for 19 months, progression free survival was better with treatment and adverse events included lymphopenia, anemia thrombocytopenia and infusion reactions; no mention of ALT elevations or hepatotoxicity).
Moreno C, Montillo M, Panayiotidis P, Dimou M, Bloor A, Dupuis J, Schuh A, et al. (2015). Ofatumumab in poor-prognosis chronic lymphocytic leukemia: a phase IV, non-interventional, observational study from the European Research Initiative on Chronic Lymphocytic Leukemia. Haematologica. (Among 103 patients with poor prognosis CLL treated with ofatumumab and followed in an observational study, the overall response rate was low [22%] but therapy was usually well tolerated and 4 subjects with anti-HBs did not develop reactivation of hepatitis B, although specific details were not provided).
Quattrocchi E, Østergaard M, Taylor PC, van Vollenhoven RF, Chu M, Mallett S, Perry H, et al. (2016). Safety of repeated open-label treatment courses of intravenous ofatumumab, a human anti-CD20 monoclonal antibody, in rheumatoid arthritis: results from three clinical trials. PLoS One. (Among 483 patients with rheumatoid arthritis in 3 clinical trials of ofatumumab given intravenously in up to 7 courses, adverse events were common, particularly infusion reactions which typically were worse with the initial infusions and lessened thereafter, infections occurred in 32-53% of subjects but no patient had reactivation of hepatitis B, one patient developed acute hepatitis B that led to hepatic failure and death; no mention of ALT elevations or hepatotoxicity).
van Imhoff GW, McMillan A, Matasar MJ, Radford J, Ardeshna KM, Kuliczkowski K, Kim W, et al. (2017). Ofatumumab versus rituximab salvage chemoimmunotherapy in relapsed or refractory diffuse large B-cell lymphoma: The ORCHARRD study. J Clin Oncol. (Among 447 patients with relapsed or refractory diffuse large B cell lymphoma treated with 3 cycles of ofatumumab- or rituximab based combination chemotherapy, response rates were similar [38% vs 42%] as were severe adverse event rates which included neutropenia and acute renal failure, but hepatotoxicity and ALT elevations were not mentioned).
Flinn IW, Hillmen P, Montillo M, Nagy Z, Illés Á, Etienne G, Delgado J, et al. (2018). The phase 3 DUO trial: duvelisib vs ofatumumab in relapsed and refractory CLL/SLL. Blood. (Among 319 patients with relapsed or refractory CLL treated with ofatumumab [twice monthly] or duvelisib [daily] adverse events for ofatumumab included infusion reactions [19%], neutropenia [21%], anemia [10%], thrombocytopenia [6%] and aminotransferase elevations [3%], but there were no drug related severe hepatic adverse events).
Rosenbaum CA, Jung SH, Pitcher B, Bartlett NL, Smith SM, Hsi E, Wagner-Johnston N, et al. (2019). Phase 2 multicentre study of single-agent ofatumumab in previously untreated follicular lymphoma: CALGB 50901 (Alliance). Br J Haematol. (Among 51 patients with follicular lymphoma treated with ofatumumab [500 or 1000 mg] monthly for up to 9 months, the most frequent adverse events w ere fatigue and pain, infusion reactions and lymphopenia, anemia and thrombocytopenia; serum ALT or AST elevations arose in ~15% of patients but were all transient, asymptomatic and less than twice ULN).
Byrd JC, Hillmen P, O'Brien S, Barrientos JC, Reddy NM, Coutre S, Tam CS, et al. (2019). Long-term follow-up of the RESONATE phase 3 trial of ibrutinib vs ofatumumab. Blood. (In long term follow up of [median 44 months] of patients participating in a controlled trial of ofatumumab vs ibrutinib [Byrd 2014], ibrutinib recipients still demonstrated a superior survival rate and there were no hepatic adverse events reported with long term use of either agent).

## OTHER REFERENCE LINKS

1 Recent References on Ofatumumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ofatumumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ofatumumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ofatumumab)